# Modafinil

## OVERVIEW

### Introduction

Modafinil and its R-enantiomer armodafinil are central nervous system stimulants used to improve wakefulness in patients with excessive sleepiness. Both modafinil and armodafinil are associated with a low rate of serum aminotransferase elevations during therapy, but they have not been implicated in cases of clinically apparent acute liver injury.

### Background

Modafinil (moe daf' i nil) is a non-amphetamine central nervous system (CNS) stimulant whose mechanism of action is not entirely clear. Modafinil is structurally unrelated to the amphetamines, and it does not appear to affect release of CNS norepinephrine or dopamine. Modafinil is a racemic mixture of S and R enantiomers, whereas armodafinil (ar" moe daf' i nil) is the R enantiomer only. Both enantiomers have CNS activating actions, but they differ in pharmacokinetics and half-life. Modafinil and armodafinil increase wakefulness and both have been shown to be helpful in conditions with excessive sleepiness including narcolepsy, obstructive sleep apnea and shift-work sleep disorder. They have also been studied off label to treat fatigue associated with chronic illness such as cancer, Parkinson’s disease, HIV/AIDs and multiple sclerosis. Modafinil was approved for use in the United States in 1998 and armodafinil in 2007. Their indications are for improvement in wakefulness in adults with excessive sleepiness due to narcolepsy, obstructive sleep apnea, and shift-work disorder. Modafinil is available in tablets of 100 and 200 mg in generic forms and under the brand name Provigil, the usual dose in adults being 200 mg once daily in the morning or an hour before a work shift. Armodafinil is available in tablets of 50, 150, 200 and 250 mg generically and under the brand name Nuvigil, the usual dose in adults being 150 to 250 mg once daily. Armodafinil is also approved for treatment of sleepiness due to jet lag, a lower dose of 50 to 150 mg being recommended. The most common side effects of both agents include headache, anxiety nervousness, nausea, decreased appetite, palpitations and disturbed sleep. Modafinil and armodafinil are now classified as category IV controlled substances, indicating that they have a potential for abuse and can lead to physical or psychological dependence. Rare but potentially severe adverse reactions include rash and severe hypersensitivity reactions such as drug-reaction with eosinophilia and systemic symptoms (DRESS), Stevens-Johnson syndrome, and toxic epidermal necrolysis. Also reported are cardiac adverse events and acute psychiatric syndromes such as mania, delusions, hallucinations, and suicidal ideation.

### Hepatotoxicity

In clinical trials, modafinil and armodafinil were associated with a low rate of serum aminotransferase and alkaline phosphatase elevations (<1%). Furthermore, despite widescale use, there have not been reports of clinically apparent liver injury due to modafinil or armodafinil. Rare instances of hypersensitivity reactions and even Stevens Johnson syndrome have been reported after modafinil use and these reactions may be accompanied by evidence of hepatic involvement or injury.

Likelihood score: E (unlikely causes of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which modafinil and armodafinil might cause liver injury is unknown. Modafinil and armodafinil are extensively metabolized in the liver largely by CYP 3A4 and 2C91 and are susceptible to drug-drug interactions with agents that are substrates for these microsomal enzymes.

Drug Class: CNS Stimulants, Narcolepsy Agents

Other Drugs in the Subclass, Narcolepsy Agents: Amphetamines, Dextroamphetamine, Methylphenidate, Oxybate, Pitolisant, Solriamfetol

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Armodafinil – Generic, Nuvigil®

Modafinil – Generic, Provigil®

DRUG CLASS

Central Nervous System Stimulants

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Armodafinil) (Armodafinil)

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Modafinil) (Modafinil)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Armodafinil | 112111-43-0 | C15-H15-N-O2-S
Modafinil | 68693-11-8 | C15-H15-N-O2-S

## ANNOTATED BIBLIOGRAPHY

References updated: 18 August 2021

Zimmerman HJ. Methylphenidate. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 712. (Expert review of hepatotoxicity published in 1999; modafinil and armodafinil are not mentioned).
Larrey D, Ripault MP. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 443-62. (Review of hepatotoxicity of psychotropic agents does not discuss modafinil and armodafinil).
Westfall TC, Macarthur H, Westfall DP. Narcolepsy and sleep/wake imbalance. Adrenergic agonists and antagonists. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 207. (Textbook of pharmacology and therapeutics).
(1998). Randomized trial of modafinil for the treatment of pathological somnolence in narcolepsy. US Modafinil in Narcolepsy Multicenter Study Group. Ann Neurol. (Controlled trial of modafinil [200 or 400 mg] vs placebo for 9 weeks; modafinil demonstrated an excellent safety profile for up to 40 weeks of open label treatment; “there were few clinically meaningful changes in laboratory values”).
(2000). Randomized trial of modafinil as a treatment for the excessive daytime somnolence of narcolepsy. US Modafinil in Narcolepsy Multicenter Study Group. Neurology. (Controlled 9 week trial of two doses of modafinil [200 and 400 mg] vs placebo in 271 patients with narcolepsy: “There were no meaningful differences among treatment groups at week 9 in clinical laboratory test results”).
Mitler MM, Harsh J, Hirshkowitz M, Guilleminault C. (2000). Long-term efficacy and safety of modafinil (PROVIGIL((R))) for the treatment of excessive daytime sleepiness associated with narcolepsy. Sleep Med. (478 adults with narcolepsy were enrolled in two 40-week, open label extension studies using 200-400 mg of modafinil daily; common side effects were headache, nervousness, and nausea; clinically significant elevations in ALT occurred in 6 [1.5%] and total bilirubin in 1 patient, but no other details given).
Moldofsky H, Broughton RJ, Hill JD. (2000). A randomized trial of the long-term, continued efficacy and safety of modafinil in narcolepsy. Sleep Med. (69 patients with narcolepsy were treated for 16 weeks in an open label extension study; mean ALT levels did not change, only 2 patients had concurrent increase in ALT and AST, but none developed jaundice).
Hoover-Stevens S, Kovacevic-Ristanovic R. (2000). Management of narcolepsy in pregnancy. Clin Neuropharmacol. (Review of the efficacy of medications for narcolepsy and their safety during pregnancy and breast feeding; modafinil is not discussed).
(2004). New indications for modafinil (Provigil). Med Lett Drugs Ther. (Brief review of modafinil and its expanded indications for sleepiness due to work-shift sleep disorder and sleep apnea syndrome; “Increases in aminotransferase activity have been reported”).
Stankoff B, Waubant E, Confavreux C, Edan G, Debouverie M, Rumbach L, Moreau T, et al., French Modafinil Study Group. (2005). Modafinil for fatigue in MS: a randomized placebo-controlled double-blind study. Neurology. (Controlled trial of escalating doses of modafinil vs placebo for 5 weeks in 115 patients with multiple sclerosis; “There was no major safety concern”).
Wigal SB, Biederman J, Swanson JM, Yang R, Greenhill LL. (2006). Efficacy and safety of modafinil film-coated tablets in children and adolescents with or without prior stimulant treatment for attention-deficit/hyperactivity disorder: pooled analysis of 3 randomized, double-blind, placebo-controlled studies. Prim Care Companion J Clin Psychiatry. (Of 638 children or adolescents treated with modafinil or placebo, side effects were insomnia, headache and decreased appetite; no mention of liver related side effects).
Roth T, Schwartz JR, Hirshkowitz M, Erman MK, Dayno JM, Arora S. (2007). Evaluation of the safety of modafinil for treatment of excessive sleepiness. J Clin Sleep Med. (Summary of results from 6 randomized controlled trials of modafinil for excessive sleepiness in 1529 patients treated for up to 12 weeks; elevations of ALT above 3 times the ULN occurred in <1% of patients; one serious adverse event was listed as abnormal liver enzymes and probably due to modafinil).
Janeiro M, Camblor E, Fernández R, Núñez D. (2007). Rev Esp Anestesiol Reanim. (24 year old man with narcolepsy receiving modafinil and clomipramine requiring surgery was found to have serum enzyme elevations; tolerated reintroduction of modafinil without recurrence; no details given).
Kumar R. (2008). Approved and investigational uses of modafinil : an evidence-based review. Drugs. (Review of pharmacology, clinical efficacy and safety of modafinil; a single case of fatal, multiorgan [including liver] hypersensitivity has been reported).
Lankford DA. (2008). Armodafinil: a new treatment for excessive sleepiness. Expert Opin Investig Drugs. (Systematic review of armodafinil for excessive sleepiness; no discussion of liver related adverse events; 1 case of Stevens Johnson syndrome and 1 of severe hypersensitivity response reported with modafinil).
Rabkin JG, McElhiney MC, Rabkin R, McGrath PJ. (2010). Modafinil treatment for fatigue in HIV/AIDS: a randomized placebo-controlled study. J Clin Psychiatry. (115 patients with HIV/AIDs were treated with modafinil or placebo for 4 weeks; no mention of liver adverse events).
Rosenberg RP, Bogan RK, Tiller JM, Yang R, Youakim JM, Earl CQ, Roth T. (2010). A phase 3, double-blind, randomized, placebo-controlled study of armodafinil for excessive sleepiness associated with jet lag disorder. Mayo Clin Proc. (427 adults were treated with armodafinil [50 or 150 mg] or placebo for 3 days after flight from US to France; side effects were headache, nausea and diarrhea; no mention of serum enzyme results).
Davies M, Wilton L, Shakir S. (2013). Safety profile of modafinil across a range of prescribing indications, including off-label use, in a primary care setting in England: results of a modified prescription-event monitoring study. Drug Saf. (Among 1096 patients prescribed modafinil by UK primary care physicians who filled out a questionnaire regarding its effects, indications were narcolepsy in 24%, "lassitude" in 24% and sleep apnea in 10%, while adverse reactions were uncommon [27 in 17 patients: 1.7%]; no mention of ALT elevations or hepatotoxicity).
Spathis A, Fife K, Blackhall F, Dutton S, Bahadori R, Wharton R, O'Brien M, et al. (2014). Modafinil for the treatment of fatigue in lung cancer: results of a placebo-controlled, double-blind, randomized trial. J Clin Oncol. (Among 160 patients with lung cancer treated with modafinil or placebo for 28 days, fatigue scores improved to the same degree in both groups and adverse event rates were similar as well; no mention of ALT elevations or hepatotoxicity).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to modafinil or armodafinil).
Silveira MG, Gossard AA, Stahler AC, Jorgensen RA, Petz JL, Ali AH, Lindor KD. (2017). A randomized, placebo-controlled clinical trial of efficacy and safety: modafinil in the treatment of fatigue in patients with primary biliary cirrhosis. Am J Ther. (Among 40 patients with primary biliary cirrhosis and fatigue who were treated with modafinil or placebo for 12 weeks, fatigue scores improved in a similar percentage of both groups [18% and 13%] and adverse events included headache, rash and diarrhea, while liver test results did not change in either group).
Thorpy MJ. (2020). Recently approved and upcoming treatments for narcolepsy. CNS Drugs. (Review of the mechanism of action, pharmacology, drug-drug interactions, clinical efficacy and safety of newly approved medications for narcolepsy including pitolisant and solriamfetol: no mention of ALT elevations or hepatotoxicity).
Nourbakhsh B, Revirajan N, Morris B, Cordano C, Creasman J, Manguinao M, Krysko K, et al. (2021). Safety and efficacy of amantadine, modafinil, and methylphenidate for fatigue in multiple sclerosis: a randomised, placebo-controlled, crossover, double-blind trial. Lancet Neurol. (In a placebo controlled, 4-period, crossover trial of amantadine, modafinil and methylphenidate for up to 6 weeks, none of the drugs were superior to placebo in improving fatigue, but all three were associated with more side effects than placebo; ALT elevations and hepatotoxicity were not mentioned).
Inoue Y, Tabata T, Tsukimori N. (2021). Efficacy and safety of modafinil in patients with idiopathic hypersomnia without long sleep time: a multicenter, randomized, double-blind, placebo-controlled, parallel-group comparison study. Sleep Med. (Among 71 Japanese patients with hypersomnia treated with modafinil or placebo, sleep time increased by 5 minutes with modafinil while adverse events included headache, dry mouth, and nausea, but there were no “significant” serious adverse events and “no notable clinical changes were reported in either group with regard to clinical laboratory tests”).

## OTHER REFERENCE LINKS

1 Recent References on Modafinil, Armodafinil: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Modafinil+Armodafinil+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Modafinil, Armodafinil: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Modafinil+Armodafinil)